# Carbinoxamine

## OVERVIEW

### Introduction

Carbinoxamine is a first generation antihistamine that is used for symptoms of allergic rhinitis and the common cold. Carbinoxamine has not been linked to instances of clinically apparent acute liver injury.

### Background

Carbinoxamine (kar" bin ox' a meen) is a first generation antihistamine that is used for alleviation of symptoms of allergic rhinitis and the common cold, including sneezing, cough, runny note, watery eyes and itching. Carbinoxamine also has mild anticholinergic effects. After reports of deaths in children less than 2 years of age who were taking carbinoxamine, its use has been restricted to adults and children over the age of 2. Carbinoxamine is currently available by prescription only in 4 mg tablets and as syrup (4 mg/5 mL) in several generic forms and under the brand name Palgic. The recommended adult oral dose is 4 to 8 mg one to four times daily. Common side effects include sedation, impairment of motor function, confusion, dizziness, blurred vision, dry mouth and throat, palpitations, tachycardia, abdominal distress, constipation and headache. Antihistamines can worsen urinary retention and glaucoma.

### Hepatotoxicity

Like many first generation antihistamines, carbinoxamine has not been linked to liver test abnormalities or to clinically apparent liver injury. The reason for its hepatic safety may relate to low daily dose and limited duration of use.

Likelihood score: E (unlikely to be a cause of clinically apparent liver injury).

References on the safety and potential hepatotoxicity of carbinoxamine and other antihistamines are given together in the overview section on antihistamines.

Drug Class: Antihistamines

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Carbinoxamine – Generic, Palgic®

DRUG CLASS

Antihistamines

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Carbinoxamine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Carbinoxamine | 486-16-8 | C16-H19-Cl-N2-O | Carbinoxamine Chemical Structure

## OTHER REFERENCE LINKS

1. Recent References on Carbinoxamine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Carbinoxamine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Carbinoxamine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Carbinoxamine)